# Proton Pump Inhibitors

## OVERVIEW

The proton pump inhibitors (PPIs) are the most potent suppressants of gastric acid secretion available and are used widely in the therapy of gastroesophageal reflux and peptic ulcer disease. PPIs are prodrugs that require gastric acid for their activation. After absorption they diffuse into the parietal cells of the stomach and accumulate in the acidic secretory canaliculi. The activated form of the PPIs binds covalently to the H+/K+-ATPase of the acid-producing parietal cell, inactivating the pump molecule that transports protons (H+ molecules) into the gastric lumen. While the half-life of the PPIs is measured in hours, the activated form is trapped in the parietal cell and inhibition of the proton pump generally lasts for 24 to 48 hours. Oral forms of the PPIs are rapidly absorbed and decrease gastric acidity by 80% to 95%, although peak inhibition may require several days. More rapid inhibition may be achieved by use of intravenous formulations. The PPIs are metabolized by the hepatic cytochrome P450 system (predominantly CYP 2C19 and 3A4), but are extremely well tolerated and associated with few adverse events. Liver injury due to PPIs has been reported, but is uncommon in view of the millions of individuals who take these agents.

Six PPIs are currently approved for use in the United States in various dosage forms, including enteric-coated tablets and gelatin capsules, delayed-release tablets and powdered forms for intravenous use. The initial PPI approved for use was omeprazole (1989: Prilosec) followed by lansoprazole (1995: Prevacid), rabeprazole (1999: Aciphex), pantoprazole (2000: Protonix), esomeprazole (2001: Nexium, the S-isomer of omeprazole), and dexlansoprazole (2009: Dexilant, the R-isomer of lansoprazole). Most are now available in generic forms. Omeprazole, esomeprazole and lansoprazole are also available in over-the-counter formulations.

Side effects of PPIs are uncommon, usually mild, and include nausea, abdominal discomfort, constipation, flatulence and diarrhea. Less common side effects include myopathy, arthralgias, headaches and skin rash. Rare instance of acute liver injury have been reported with most of the PPIs. In view of the wide scale use of the PPIs, clinically apparent liver injury is exceedingly rare. Each PPI is discussed separately in LiverTox, with references given after each, as the pattern of hepatic injury that occurs with their use is somewhat different, although all appear to share a tendency to cause hepatocellular liver injury with a short latency, within 4 weeks of starting, and rapid recovery on stopping.

- Dexlansoprazole
- Esomeprazole
- Lansoprazole
- Omeprazole
- Pantoprazole
- Rabeprazole

Drug Class: Antiulcer Agents